# Alirocumab

## OVERVIEW

### Introduction

Alirocumab is a human monoclonal antibody to PCSK9 (proprotein convertase subtilisin/kexin type 9), a circulating protein that modulates the activity of the LDL cholesterol receptor in the liver. The monoclonal antibody lowers serum LDL cholesterol and is used to treat severe hypercholesterolemia. Alirocumab therapy has been associated with a low rate of serum aminotransferase elevations and has yet to be linked to instances of clinically apparent acute liver injury.

### Background

Alirocumab (al" i rok' ue mab) is a human IgG1 monoclonal antibody to proprotein convertase subtilisin/kexin type 9 (PCSK9), a serine protease that decreases the activity of the LDL cholesterol receptor in the liver. Inhibition of PCSK9 increases the low density lipoprotein (LDL) cholesterol receptor, leading to an increased uptake of LDL particles and a decrease in serum LDL cholesterol. Patients with a genetic deficiency in PCSK9 have low levels of LDL cholesterol, and inhibition of the protein activity with monoclonal antibody leads to a marked lowering of LDL cholesterol. In several controlled trials, alirocumab was shown to lower LDL cholesterol in persons with heterozygosity for familial hypercholesterolemia and in persons at risk for atherosclerosis who have been unable to achieve adequate cholesterol lowering with standard lipid lowering agents (statins). Alirocumab was approved for use in the United States in 2015. The current indications are limited to patients with severe hypercholesterolemia who are heterozygous for familial hypercholesterolemia or who have had clinical complications of atherosclerosis and an inadequate response to standard therapies. Alirocumab should be given in combination with advice on diet and exercise and is usually used in combination with oral lipid lowering agents such as statins. Alirocumab is available in solution in single use syringes or pens of 75 or 150 mg/mL under the brand name Praluent. The recommended initial dose is 75 mg administered subcutaneously every two weeks, which can be raised to 150 mg every two weeks based upon tolerance and response. Side effects are uncommon and rarely serious, but include injection site reactions (7%) and myalgia (4%). Rare, but potentially serious side effects may include memory impairment, neurocognitive defects, confusion and hypersensitivity reactions.

### Hepatotoxicity

In premarketing studies, liver test abnormalities were uncommon in patients taking alirocumab and rates of abnormalities were only slightly higher than in patients receiving placebo injections. Some degree of ALT elevation was reported in 2.5% with alirocumab vs 1.7% with placebo injections. ALT or AST values greater than 3 times the upper limit of normal (ULN) occurred in 1.7% of persons on alirocumab vs 1.4% on placebo. No instances of acute, clinically apparent liver injury attributed to alirocumab were reported during the prelicensure evaluation and none have been reported since. However, alirocumab has had limited use and has been available commercially for a short time only.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Alirocumab is a human monoclonal antibody and is metabolized in many tissues to polypeptides and amino acids which are unlikely to be toxic. Monoclonal antibody therapy sometimes causes immune mediated liver injury, but such events have not been described in alirocumab or evolocumab.

### Outcome and Management

Therapy with alirocumab and other monoclonal antibodies to PCSK9 have been well tolerated with rates of adverse events similar to those with placebo or comparator treatments. Local injection site reactions occur with these agents, but are generally mild and improve with continued therapy. Monoclonal antibodies to PCSK9 has not been linked to significant elevations in serum enzymes or bilirubin or to clinically apparent liver injury. Patients who develop serum aminotransferase elevations above 3 times the upper limit of normal should be evaluated for other causes of liver injury including drug-induced injury from another antilipemic agent.

Drug Class: Antilipemic Agents; Monoclonal Antibodies, Anti-PCSK9

Other Drugs in the Class: Evolocumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Alirocumab – Praluent®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Alirocumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Alirocumab | 1245916-14-6 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 19 February 2018

Zimmerman HJ. Drugs used in the treatment of hypercholesterolemia and hyperlipidemia. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 660-2. (Expert review of hepatotoxicity of lipid lowering drugs published in 1999; before the availability of alirocumab).
Halegoua-De Marzio D, Navarro VJ. Lipid-regulating agents. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 5268. (Review of hepatotoxicity of lipid lowering drugs before the availability of alirocumab).
Bersot TP. Drug therapy for hypercholesterolemia and dyslipidemia. In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 11th ed. New York: McGraw-Hill, 2006, pp. 877-908. (Textbook of pharmacology and therapeutics).
Stein EA, Gipe D, Bergeron J, Gaudet D, Weiss R, Dufour R, Wu R, et al. Effect of a monoclonal antibody to PCSK9, REGN727/SAR236553, to reduce low-density lipoprotein cholesterol in patients with heterozygous familial hypercholesterolaemia on stable statin dose with or without ezetimibe therapy: a phase 2 randomised controlled trial. Lancet 2012; 380 (9836): 29-36. (Among 77 patients with heterozygosity for familial hypercholesterolemia on high doses of statins treated with 1 of 4 regimens of alirocumab or placebo for 12 weeks, LDL cholesterol levels decreased in a dose dependent manner; there were no serious adverse events related to therapy and no patient had serum ALT elevations above 3 times ULN). 22633824
McKenney JM, Koren MJ, Kereiakes DJ, Hanotin C, Ferrand AC, Stein EA. Safety and efficacy of a monoclonal antibody to proprotein convertase subtilisin/kexin type 9 serine protease, SAR236553/REGN727, in patients with primary hypercholesterolemia receiving ongoing stable atorvastatin therapy. J Am Coll Cardiol 2012; 59: 2344-53. (Among 183 patients with hypercholesterolemia [LDL-cholesterol >100 mg/dL], despite maximal statin doses, treated with anti-PCSK9 or placebo every 2 or 4 weeks for 12 weeks, none had ALT elevations above 3 times ULN or significant changes in laboratory values). 22463922
Roth EM, McKenney JM, Hanotin C, Asset G, Stein EA. Atorvastatin with or without an antibody to PCSK9 in primary hypercholesterolemia. N Engl J Med 2012; 367: 1891-900. (Among 92 patients with hypercholesterolemia treated with atorvastatin and either alirocumab or placebo for 8 weeks, mean decline in LDL cholesterol was 66-73% with alirocumab and there were no episodes of ALT elevations above 3 times ULN during therapy). 23113833
Giugliano RP, Desai NR, Kohli P, Rogers WJ, Somaratne R, Huang F, Liu T, et al.; LAPLACE-TIMI 57 Investigators. Efficacy, safety, and tolerability of a monoclonal antibody to proprotein convertase subtilisin/kexin type 9 in combination with a statin in patients with hypercholesterolaemia (LAPLACE-TIMI 57): a randomised, placebo-controlled, dose-ranging, phase 2 study. Lancet 2012; 380 (9858): 2007-17. (Among 631 patients with hypercholesterolemia, despite statin use, treated with anti-PCSK9 [70, 105 or 140 mg] or placebo every 2 or 4 weeks, a marked, dose related decline in LDL cholesterol occurred and there were no treatment related serious adverse events and no changes in laboratory values from baseline compared to placebo). 23141813
Kereiakes DJ, Robinson JG, Cannon CP, Lorenzato C, Pordy R, Chaudhari U, Colhoun HM. Efficacy and safety of the proprotein convertase subtilisin/kexin type 9 inhibitor alirocumab among high cardiovascular risk patients on maximally tolerated statin therapy: The ODYSSEY COMBO I study. Am Heart J 2015 169: 906-915.e13. (Among 316 patients with coronary artery disease and hypercholesterolemia, despite high doses of statins, who were treated with alirocumab [75 mg] or placebo injections every 2 weeks, LDL cholesterol levels decreased by 48% and adverse events including laboratory test abnormalities were similar between groups). 26027630
Robinson JG, Farnier M, Krempf M, Bergeron J, Luc G, Averna M, Stroes ES, et al.; ODYSSEY LONG TERM Investigators. Efficacy and safety of alirocumab in reducing lipids and cardiovascular events. N Engl J Med 2015; 372: 1489-99. (Among 2341 patients at high or moderate risk for cardiovascular events and hypercholesterolemia, despite high doses of statins, who were treated with alirocumab [150 mg] or placebo injections every two weeks, adverse events more common with alirocumab included injection site reactions [5.9% vs 4.2%], myalgia [5.4% vs 2.9%], neurocognitive events [1.2% vs 0.5%] and ophthalmologic events [2.9% vs 1.9%], but ALT elevations above 3 times ULN occurred at similar rates [1.8% vs 2.1%]). 25773378
Cannon CP, Cariou B, Blom D, McKenney JM, Lorenzato C, Pordy R, Chaudhari U, et al.; ODYSSEY COMBO II Investigators. Efficacy and safety of alirocumab in high cardiovascular risk patients with inadequately controlled hypercholesterolaemia on maximally tolerated doses of statins: the ODYSSEY COMBO II randomized controlled trial. Eur Heart J 2015; 36: 1186-94. (Among 720 patients with hypercholesterolemia, despite high doses of statins, treated with either alirocumab or ezetimibe for up to 104 weeks, rates of side effects were similar in the two groups and ALT elevations above 3 times ULN occurred in 1.7% on alirocumab vs 0.4% on ezetimibe, but there were no episodes of clinically apparent liver injury). 25687353
Koren MJ, Roth EM, McKenney JM, Gipe D, Hanotin C, Ferrand AC, Wu R, et al. Safety and efficacy of alirocumab 150 mg every 2 weeks, a fully human proprotein convertase subtilisin/kexin type 9 monoclonal antibody: A Phase II pooled analysis. Postgrad Med 2015; 127: 125-32. (Pooled analysis of 3 phase II trials of alirocumab [n=108] vs placebo [n=77] for 8-12 weeks, found no significant difference in rates of adverse events and no instance of ALT elevations above 3 times ULN in either group). 25609019
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 41 cases were attributed to lipid lowering agents including 31 to statins, 5 to niacin and 5 to fibrates, but none to alirocumab or evolocumab). 25754159
Navarese EP, Kolodziejczak M, Schulze V, Gurbel PA, Tantry U, Lin Y, Brockmeyer M, et al. Effects of proprotein convertase subtilisin/kexin type 9 antibodies in adults with hypercholesterolemia: a systematic review and meta-analysis. Ann Intern Med 2015; 163: 40-51. (Systematic review of the literature on efficacy and safety of anti-PCSK9 monoclonal antibody therapy [both alirocumab and evolocumab] in patients with hypercholesterolemia concludes that these agents are safe and effective, leading to marked reductions in LDL cholesterol without increasing serious adverse events; does not discuss ALT elevations or hepatotoxicity). 25915661
Moriarty PM, Thompson PD, Cannon CP, Guyton JR, Bergeron J, Zieve FJ, Bruckert E, et al.; ODYSSEYALTERNATIVE Investigators. Efficacy and safety of alirocumab vs ezetimibe in statin-intolerant patients, with a statin rechallenge arm: The ODYSSEYALTERNATIVE randomized trial. J Clin Lipidol 2015; 9: 758-69. (Among 313 patients with hypercholesterolemia and statin intolerance treated with alirocumab or ezetimibe or atorvastatin for 24 weeks, alirocumab produced greater reductions in LDL-cholesterol than ezetimibe with slightly lower rates of myalgia than atorvastatin [25% vs 27%], and there were no ALT elevations above 3 times ULN in any group). 26687696
Jones PH, Bays HE, Chaudhari U, Pordy R, Lorenzato C, Miller K, Robinson JG. Safety of alirocumab (a PCSK9 monoclonal antibody) from 14 randomized trials. Am J Cardiol 2016; 118: 1805-11. (Among 5234 patients treated with alirocumab or placebo or ezetimide in 14 controlled trials, overall adverse event rates, including serious events and deaths, were similar in the three groups, although local injection reactions were more common with alirocumab; rates of ALT elevations were also similar [2.7 and 2.9% vs 2.3% with placebo and 2.6% with ezetimibe] and there were no cases of ALT elevations with jaundice that could not be attributed to other causes [2 in patients treated with alirocumab, 2 with placebo]). 27729106
Stroes E, Guyton JR, Lepor N, Civeira F, Gaudet D, Watts GF, Baccara-Dinet MT, et al.; ODYSSEY CHOICE II Investigators. Efficacy and safety of alirocumab 150 mg every 4 weeks in patients with hypercholesterolemia not on a statin therapy: the ODYSSEY CHOICE II Study. J Am Heart Assoc 2016; 5. pii: e003421. (Among 233 patients with hypercholesterolemia, not on statin therapy, who were treated with one of two doses of alirocumab or placebo injections for 24 weeks, adverse event rates were similar except for injection site reactions [13.8% vs 3.5% vs none with placebo], and ALT elevations above 3 times ULN occurred in only 1 alirocumab [0.6%] vs no placebo recipient). 27625344
Orringer CE, Jacobson TA, Saseen JJ, Brown AS, Gotto AM, Ross JL, Underberg JA. Update on the use of PCSK9 inhibitors in adults: Recommendations from an Expert Panel of the National Lipid Association. J Clin Lipidol 2017; 11: 880-90. (Revised recommendations on the use of monoclonal anti-PCSK9 therapies by an expert panel suggesting their use in all patients at high or moderate risk for atherosclerotic cardiovascular disease who have intolerance or inadequate control of cholesterol levels using maximal doses of conventional agents). 28532784
Bays HE, Leiter LA, Colhoun HM, Thompson D, Bessac L, Pordy R, Toth PP. Alirocumab treatment and achievement of non-high-density lipoprotein cholesterol and apolipoprotein B goals in patients with hypercholesterolemia. J Am Heart Assoc 2017; 6. pii: e005639. (Among 4983 patients with hypercholesterolemia enrolled in 10 controlled trials of alirocumab, total and serious adverse event rates were similar in all groups except for injection site reactions which were greater with alirocumab; no mention of ALT elevations or hepatotoxicity). 28862926
El Shahawy M, Cannon CP, Blom DJ, McKenney JM, Cariou B, Lecorps G, Pordy R, Chaudhari U, Colhoun HM et al. Efficacy and safety of alirocumab versus ezetimibe over 2 years (from ODYSSEY COMBO II). Am J Cardio 2017; 120: 931-9. (Among 720 patients with inadequate control of cholesterol levels with maximal doses of statins who were treated with alirocumab or ezetimibe for up to 2 years, adverse event rates were similar, ALT elevations above 3 times ULN occurred in 2.1% on alirocumab vs 0.8% on ezetimibe, but the abnormalities were usually a single value and no patient developed clinically apparent liver injury). 28750828

## OTHER REFERENCE LINKS

1. Recent References on Alirocumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Alirocumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Alirocumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Alirocumab)